# Weight Loss Agents

## OVERVIEW

While many agents have been developed to aid in weight loss, few have withstood critical assessment for safety and efficacy until the development of the glucagon-like polypeptide-1 (GLP-1) receptor agonists that were initially approved for therapy of diabetes. The GLP-1 receptor agonists such as liraglutide and semaglutide have transformed weight management and therapy of overweight and obesity. Furthermore, tirzepatide, a dual receptor agonist that combines receptor agonism for GLP-1 as well as for glucose-dependent insulintropic polypeptide (GIP), appears to provide increased efficacy in weight loss.

All weight loss agents are held to a high standard for safety and tolerability, because they are often used by otherwise healthy individuals who may be driven by concerns over appearance rather than health. Furthermore, all weight loss medications should be used as a part of a coordinated weight loss program that includes modification of behaviors, a reduced calorie diet, and increased physical activity or exercise.

Drugs for weight loss can be separated into those that suppress appetite (such as diethylpropion and phentermine) and those that block absorption of calories (orlistat). The anorexic agents that have been used for weight loss include sympathomimetic agents (such as diethylpropion, and phentermine), serotonin and norepinephrine reuptake inhibitors (bupropion, fluoxetine, sibutramine), serotonin agonists (lorcaserin), GABAergic agents (topiramate, zonisamide) and cannabinoid antagonists (rimonabant). The cannabinoid antagonist rimonabant was shown to induce weight loss but was never approved in the United States because of concerns over suicidal ideation and behaviors associated with its use. Sibutramine (Meridia) which has both sympathomimetic activity as well as serotonin and norepinephrine reuptake inhibitory activity, was approved in the United States in 1997 and used widely for several years in the United States, but was then withdrawn in 2010 because of concerns over increased risks for cardiovascular adverse events including myocardial infarction and stroke. Lorcaserin (Belviq), a serotonin agonist, was approved as a weight loss agent in 2012 but was withdrawn in 2020 because of concerns of increased risk for cancer. Second generation weight loss agents still in current use include the combination of phentermine and topiramate (Qsymia: 2012); a fixed dose combination of the antidepressant bupropion and the opioid receptor antagonist naltrexone (Contrave: 2014).

The GLP-1 receptor agonists can be considered third generation of weight loss agents. They act by suppressing appetite and delaying gastric emptying. They were initially approved as therapy of type 2 diabetes and were found to induce considerable weight loss. Indications for the GLP-1 receptor agonists were expanded to include weight loss, usually with a change in dose regimen. The GLP-1 based weight loss agents include [as of mid-2025): the injectable GLP-1 agonist liraglutide which was approved for improvement in glycemic control in type 2 diabetes in 2012 and, when given in a higher dose, for weight loss in 2014 (Saxenda), the injectable GLP-1 agonist semaglutide which was approved for type 2 diabetes in 2017 (Ozempic) and in higher doses for weight loss in 2021 (Wegovy); the injectible dual GLP-1 and GIP agonist, tirzepatide which was approved glycemic control in type 2 diabetes in 2022 (Mounjaro) and for weight management in 2024 (Zepbound). Still in clinical trials for obesity are other GLP-1 agonists including oral formulations of semaglutide (Rybelsus) as well as triple agonist agents.

Drugs that suppress appetite generally affect appetite centers in the central nervous system (CNS) and can have other CNS effects such as nervousness, excitability, insomnia, mood changes, and headache. Weight loss agents are generally labeled with a warning of suicidal ideation and behavior, although large clinical trials of these agents have not shown an increase in suicide rate. Drugs that affect absorption of nutrients often have other gastrointestinal side effects such as diarrhea, flatulence and abdominal bloating. Because GLP-1 also causes delayed gastric emptying, the GLP-1 agonists have been linked to instances of gastroparesis. Rapid weight loss is well known to be a risk factor for gallstone formation and their complications, and most clinical trials of GLP-1 receptor agonists have reported a slight increased risk for cholecystitis with therapy. Idiosyncratic liver injury is rare with all of the currently approved medications for weight loss.

The following weight loss agents are discussed individually:

• Bupropion

• Diethylpropion

• Liraglutide

• Lorcaserin

• Naltrexone

• Naltrexone-Bupropion

• Orlistat

• Phentermine

• Phentermine-Topiramate

• Semaglutide

• Sibutramine

• Tirzepatide

## ANNOTATED BIBLIOGRAPHY

References updated: 1 July 2025

Abbreviations used: sc, subcutaneous, GLP-1, glucagon-like polypeptide 1; GIP, glucose-dependent insulintropic polypeptide.

Kang JG, Park CY. Anti-obesity drugs: a review about their effects and safety. Diabetes Metab J 2012; 36: 13-25. (Review of the safety and efficacy of current and potentially future medications for obesity; mentions that phentermine has been available for 50 years, but there is little data on its long term efficacy and safety). 22363917
Yanovski SZ, Yanovski JA. Long-term drug treatment for obesity: a systematic and clinical review. JAMA 2014; 311: 74-86. (Systematic review of the literature on the efficacy of long term use of drugs for obesity that were FDA approved [at the time of the analysis] mentions that phentermine, diethylpropion and phendimetrazine are approved for short term use only, but that orlistat, lorcaserin and phentermine/topiramate are approved for long term use although their efficacy is modest; no discussion of hepatotoxicity). 24231879
Diet, drugs, devices, and surgery for weight management. Med Lett Drugs Ther 2018; 60 (1548): 91-8. (Concise review of the medical and surgical therapies for obesity mentions that orlistat is modestly effective in inducing weight loss and that “severe liver injury has been reported rarely, but no cause-and-effect relationship has been established”; discussion of other weight loss agents [phentermine/topiramate, naltrexone/bupropion, lorcaserin and liraglutide] does not mention ALT elevations or hepatotoxicity). 29913463
Saunders KH, Umashanker D, Igel LI, Kumar RB, Aronne LJ. Obesity pharmacotherapy. Med Clin North Am 2018; 102: 135-48. (Review of the pharmacotherapy of obesity focusing upon the 6 most commonly used medications, discusses the common side effects of the agents, but does not discuss hepatotoxicity). 29156182
Wilding JPH, Batterham RL, Calanna S, Davies M, Van Gaal LF, Lingvay I, McGowan BM, et al; STEP 1 Study Group. Once-weekly semaglutide in adults with overweight or obesity. N Engl J Med. 2021;384:989-1002.. (Among 1961 obese or overweight adults treated with subcutaneous [sc] injections of semaglutide [2.4 mg] vs placebo once weekly for 68 weeks, the estimated mean weight loss was -15% vs -2%, while side effects rates were 90% vs 86% and were serious in 10% vs 6%, hepatobiliary disorders were more frequent with semaglutide [1.3% vs none] as were gallbladder related disorders [2.6% vs 1.2%], no mention of drug-induced liver injury or ALT elevations). 33567185
Wadden TA, Bailey TS, Billings LK, Davies M, Frias JP, Koroleva A, Lingvay I, et al; STEP 3 Investigators. Effect of subcutaneous semaglutide vs placebo as an adjunct to intensive behavioral therapy on body weight in adults with overweight or obesity: the STEP 3 randomized clinical trial. JAMA. 2021;325:1403-1413.. (Among 611 overweight or obese adults treated with sc semaglutide [2.4 mg] vs placebo injections weekly for 68 weeks, the mean weight change was -16% vs -6%, while serious adverse events arose in 9% vs 3%, gastrointestinal side effects in 83% vs 63%, discontinuations for side effects in 6% vs 3%, gallbladder disorders in 5% vs 1.5%; no mention of ALT elevations or hepatotoxicity). 33625476
Yanovski SZ, Yanovski JA. Progress in pharmacotherapy for obesity. JAMA. 2021;326:129-130.. (Concise review of the efficacy and safety of the five FDA-approved anti-obesity medications at the time, which included orlistat, phentermine/topiramate, naltrexone/bupropion, liraglutide and semaglutide). 34160571
Drugs and devices for weight management. Med Lett Drugs Ther. 2022;64(1651):81-88.. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs approved for weight management including liraglutide and semaglutide). 35650672
Tirzepatide (Zepbound) for chronic weight management. Med Lett Drugs Ther. 2023;65(1692):205-207.. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of tirzepatide shortly after its approval as therapy of overweight or obesity in the United States, mentions adverse events of gastrointestinal symptoms, injection-site reactions, gastroparesis, acute pancreatitis, gall bladder disease, and suicidal ideation and behavior but does not mention ALT elevations or hepatoxicity). 38133594
Jastreboff AM, le Roux CW, Stefanski A, Aronne LJ, Halpern B, Wharton S, Wilding JPH, et al; SURMOUNT-1 Investigators. Tirzepatide for obesity treatment and diabetes prevention. N Engl J Med. 2025;392:958-971.. (Among 2539 obese adults treated with 5, 10, or 15 mg of tirzepatide or placebo sc once weekly for 3 years, tirzepatide treatment resulted in greater mean weight loss [-12% to -20% vs -1.3%] and a lower rate of new onset diabetes [1.3% vs 13%], and both overall [85% to 88% vs 83%] and serious adverse event rates [13% to 15% vs 12%] were similar in the 2 groups, while serum ALT and AST levels decreased with tirzepatide but remained unchanged with placebo treatment). 39536238
Aronne LJ, Horn DB, le Roux CW, Ho W, Falcon BL, Gomez Valderas E, Das S, et al; SURMOUNT-5 Trial Investigators. Tirzepatide as compared with semaglutide for the treatment of obesity. N Engl J Med. 2025;393:26-36.. (Among 781 obese adults without diabetes treated with sc tirzepatide vs semaglutide for 72 weeks, weight loss was greater with tirzepatide [-20% vs -14%] while both overall [77% vs 79%] and serious events [4.8% vs 3.5%] were similar; no mention of ALT elevations or hepatic adverse events). 40353578